# Prostacyclin Analogs

## OVERVIEW

### Introduction

Prostacyclin is a small lipid eicosanoid molecule also known as prostaglandin I-2 (PGI-2) that is produced by endothelial cells and acts locally, inhibiting platelet activation and causing vasodilation. Analogs of prostacyclin have been developed as therapies of pulmonary arterial hypertension (PAH).

### Background

Prostacyclin is synthesized in endothelial cells and released in response to local factors such as inflammation and injury. Prostacyclin acts locally on receptors present on endothelial cells and platelets activating adenyl cyclase and thereby increasing intracellular cyclic adenine monophosphate (cAMP), a signaling molecule that activates multiple downstream pathways. In platelets, cAMP inhibits their activation, thus limiting the formation of platelet clots and decreasing hemostasis. In endothelial cells, intracellular cAMP activate pathways to induce smooth muscle relaxation and vasodilation. Prostacyclin is a paracrine signaling molecule, acting locally and with a very short half-life. When used as a drug, it is referred to as epoprostenol which is a potent vasodilator, particularly of the pulmonary vascular bed. Because of its short half-life and relative instability, epoprostenol requires continuous intravenous infusion and special handling. Several analogs of prostacyclin have been produced that have a longer half-life and greater stability, resulting in more favorable pharmacokinetics and bioavailability allowing administration by subcutaneous and oral routes or by inhalation. Prostacyclin analogs in clinical use in the United States include epoprostenol, iloprost and treprostinil. All three are used to treat pulmonary arterial hypertension (PAH), a severe and progressive disease marked by vasoconstriction and smooth muscle cell proliferation of the pulmonary arterioles. Importantly, PAH is associated with a relative increase in mediators of vasoconstriction (endothelin-1, thromboxane A) and a relative decrease in mediators of vasodilation (prostacyclin, nitric oxide). Modern therapy of PAH often combines antagonists of vasoconstrictors with agonists of the vasodilatory mediators. All three of the vasodilatory prostacyclin analogs require careful and monitored dose adjustments and should be administered only by physicians and health care providers trained and experienced in the management of PAH. None of the prostacyclin analogs have been convincingly linked to instances of clinically significant acute liver injury.

Epoprostenol (e" poe pros' ten nol) is the pharmaceutical name for prostacyclin, a naturally occurring metabolite of arachidonic acid that causes pulmonary arterial vasodilation and inhibits platelet activation. Epoprostenol must be given parenterally and has a short half-life (~6 minutes), for which reasons it is administered as a continuous intravenous infusion. In multiple clinical trials in patients with PAH, prolonged epoprostenol infusions led to an increase in exercise capacity (6 minute walk distance), improvement in symptoms and delay in clinical progression in patients with idiopathic and inheritable forms of PAH (WHO Group 1) and connective tissue disease-associated PAH. Epoprostenol was approved for use in the United States in 1995 and remains available generically and under the brand name Flolan. Epoprostenol is provided as a sterile powder in single use vials of 0.5 or 1.5 mg. The typical dose is 2 ng per kg body weight per minute administered via an implanted central venous catheter. The dose can be increased in increments of 1 to 2 ng/kg/min based upon clinical response and tolerance. Common side effects include dizziness, jaw pain, headache, muscle pain, gastrointestinal upset, nausea and vomiting, effects commonly associated with vasodilatory therapies. Uncommon, but potentially severe adverse events include pulmonary edema, hypotension, syncope, and bleeding. Sudden discontinuation can lead to rebound pulmonary hypertension. Side effects of the intravenous catheter required for administration include local pain, swelling and infection at the site of injection and catheter-associated bacterial infections that can be severe and result in fatality. Epoprostenol has not been associated with serum enzyme elevations above the rate in control subjects and has not been linked to instances of clinically apparent acute liver injury.

Likelihood score: E (unlikely to cause clinically apparent liver injury).

Iloprost (eye' loe prost) is a synthetic prostacyclin analog that is more stable and has a longer half-life than epoprostenol and can be given by inhalation. Chronic inhalation therapy using iloprost has been shown to improve symptoms, exercise capacity and pulmonary function in patients with PAH, WHO type 1. Iloprost was approved for use in the United States in 2004 and is usually given in combination with other agents for PAH. Iloprost is available in ampules of 10 or 20 µg/mL under the brand name Ventavis and is administered via a nebulizer in doses of 2.5 to 5.0 µg, 6 to 9 times daily. Because of its short half-life, iloprost must be administered frequently (minimum of 2 hours between doses), a requirement that limits its acceptability. Common side effects include flushing, cough, headache, dizziness, insomnia, palpitations, jaw pain, muscle pain, palpitations, nausea and vomiting. Uncommon, but potentially severe adverse events include hypotension, hemoptysis, pulmonary edema, bronchospasm and pneumonia. Iloprost has not been associated with serum enzyme elevations above the rate in control subjects and has not been linked to instances of clinically apparent acute liver injury.

Likelihood score: E (unlikely to cause clinically apparent liver injury).

Treprostinil (tre pros’ ti nil) is a tricyclic benzidine analog of prostacyclin that can be administered orally, by inhalation, subcutaneously or by intravenous infusion. It has a longer half-life (3 to 4 hours) than epoprostenol and iloprost and is stable at room temperature and neutral pH, making it more convenient to administer when given parenterally. Intravenous and subcutaneous forms of treprostinil have been found to be better accepted than other intravenously administered prostacyclin analogs and to have similar long term efficacy. Treprostinil was initially approved for use in PAH (WHO Group 1) in the United States in 2002 and is available in solution for injection in vials of 1.0, 2.5, 5.0 and 10.0 mg/mL under the brand name Remodulin, the typical dose being 1.25 to 2.5 ng/kg per minute. Treprostinil is also available as a solution for inhalation under the brand name Tyvaso in 2.9 mL ampules with 1.74 mg/ampule, the usual dose being 3 to 9 breaths four times daily. Finally, oral treprostinil tablets of 0.125, 0.25, 1 and 2.5 mg are available under the brand name Orenitram, the initial dose being 0.125 three times daily or 0.25 twice daily, with careful adjustment of dose thereafter based upon tolerance. Side effects of treprostinil are similar to those of iloprost and epoprostenol and include headache, diarrhea, nausea and vomiting, flushing, dizziness, paresthesia, muscle and jaw pain. Sudden withdrawal of therapy can cause rebound worsening of pulmonary hypertension. Inhalation therapy can cause cough. Chronic intravenous therapy with treprostinil is associated with a high rate of infusion site pain and erythema and with catheter-associated bacterial infections that can be severe and have resulted in death in rare instances. The oral form of treprostinil has limited efficacy and is considered a second line therapy of PAH generally given with other oral agents for PAH or to replace intravenous or subcutaneous treprostinil in patients with poor tolerance of the parenteral therapies. Treprostinil therapy has not been associated with serum enzyme elevations above the rate in control subjects and has not been linked to instances of clinically apparent acute liver injury.

Likelihood score: E (unlikely to cause clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which prostacyclin analogs might cause liver injury is not known. All three are eicosanoid molecules that have a relatively rapid half-life and are metabolized locally. Furthermore, the prostacyclin analogs are typically administered in low daily doses (<1 mg), doses at which direct and even idiosyncratic liver injury are rare. The prostacyclin analogs have little or no effect on cytochrome P450 enzymes and are not prone to causing drug-drug interactions. On the other hand, they are often administered with other drugs used to treat PAH such as the endothelin-1 receptor antagonists (ambrisentan, bosentan, macitentan), guanylate cyclase simulators (riociguat) or prostacyclin receptor agonists (selexipag), some of which have been linked to idiosyncratic, symptomatic acute liver injury.

Drug Class: Pulmonary Arterial Hypertension Agents

Other Drugs in the Class: Ambrisentan, Bosentan, Macitentan, Riociguat, Selexipag

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Epoprostenol – Generic, Flolan®, Veletri®

Iloprost – Ventavis®

Treprostinil – Orenitram®, Remodulin®, Tyvaso®

DRUG CLASS

Pulmonary Arterial Hypertension Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Prostacyclin%20Analogs)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Epoprostenol [Prostacyclin] | 35121-78-9 | C20-H32-O5 | Epoprostenol [Prostacyclin] chemical structure
Iloprost | 78919-13-8 | C22-H32-O4 | Iloprost chemical structure
Treprostinil | 81846-19-7 | C23-H34-O5 | Treprostinil chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 November 2016

Abbreviations used: PAH, pulmonary arterial hypertension; sc, subcutaneous; iv, intravenous.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; does not discuss epoprostenol, iloprost or treprostinil).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on drug induced liver injury; does not discuss the prostacyclin analogs).
Barnes PJ. Pharmacotherapy of pulmonary arterial hypertension. Pulmonary Pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1059-61. (Textbook of pharmacology and therapeutics).
Barst RJ, Rubin LJ, Long WA, McGoon MD, Rich S, Badesch DB, Groves BM, et al.; Primary Pulmonary Hypertension Study Group. A comparison of continuous intravenous epoprostenol (prostacyclin) with conventional therapy for primary pulmonary hypertension. N Engl J Med 1996; 334: 296-301. (Among 81 patients with pulmonary arterial hypertension [PAH] treated with continuous infusions of epoprostenol vs conventional therapy for 12 weeks found improvements in exercise capacity and pulmonary hemodynamics; side effects included nausea, headache, dizziness, jaw pain, diarrhea and flushing and 4 cases of catheter sepsis, none fatal; no mention of enzyme elevations or hepatotoxicity). 8532025
Epoprostenol for primary pulmonary hypertension. Med Lett Drugs Ther 1996; 38 (968): 14-5. (Concise summary of the mechanism of action, clinical efficacy, side effects and costs of epoprostenol shortly after its approval in the US, does not mention ALT elevations or hepatotoxicity). 8592477
Califf RM, Adams KF, McKenna WJ, Gheorghiade M, Uretsky BF, McNulty SE, Darius H, et al. A randomized controlled trial of epoprostenol therapy for severe congestive heart failure: The Flolan International Randomized Survival Trial (FIRST). Am Heart J 1997; 134: 44-54. (Among 471 patients with congestive heart failure treated with intravenous (iv) epoprostenol or standard care for up to 1.5 years, hemodynamics improved but not symptoms, exercise capacity or clinical status and patients treated with epoprostenol had an excess in early mortality largely due to worsening cardiac status; no mention of serum enzyme elevations or hepatotoxicity). 9266782
Hoeper MM, Schwarze M, Ehlerding S, Adler-Schuermeyer A, Spiekerkoetter E, Niedermeyer J, Hamm M, et al. Long-term treatment of primary pulmonary hypertension with aerosolized iloprost, a prostacyclin analogue. N Engl J Med 2000; 342: 1866-70. (Among 24 patients with PAH treated with aerosolized iloprost for 1 year, exercise capacity and hemodynamics improved, while side effects tended to be mild and liver tests “remained stable in all patients”). 10861321
Treprostinil (Remodulin) for pulmonary arterial hypertension. Med Lett Drugs Ther 2002; 44: 80-2. (Concise review of the mechanism of action, efficacy, safety and cost of subcutaneous (sc) treprostinil shortly after its approval for use in PAH in the US; mentions side effects of infusion site reactions, pump complications as well as diarrhea, jaw pain, flushing, edema and gastrointestinal hemorrhage, but does not mention hepatotoxicity). 12237619
Simonneau G, Barst RJ, Galie N, Naeije R, Rich S, Bourge RC, Keogh A, et al.; Treprostinil Study Group. Continuous subcutaneous infusion of treprostinil, a prostacyclin analogue, in patients with pulmonary arterial hypertension: a double-blind, randomized, placebo-controlled trial. Am J Respir Crit Care Med 2002; 165: 800-4. (Among 470 patients with PAH treated with continuous sc treprostinil or placebo for 12 weeks, exercise capacity, symptoms and hemodynamics improved with treprostinil while adverse events included infusion site pain [85% vs 27%], headache, diarrhea, nausea, jaw pain and edema and 3 patients had gastrointestinal bleeding; no mention of ALT elevations or hepatotoxicity). 11897647
Olschewski H, Simonneau G, Galiè N, Higenbottam T, Naeije R, Rubin LJ, Nikkho S, et al.; Aerosolized Iloprost Randomized Study Group. Inhaled iloprost for severe pulmonary hypertension. N Engl J Med 2002; 347: 322-9. (Among 203 patients with PAH treated with inhaled iloprost [6-9 times daily] or placebo for at least 12 weeks, side effects included cough, headache, flushing and jaw pain, but serum enzyme elevations and hepatotoxicity were not mentioned). 12151469
McLaughlin VV, Gaine SP, Barst RJ, Oudiz RJ, Bourge RC, Frost A, Robbins IM, et al.; Treprostinil Study Group. Efficacy and safety of treprostinil: an epoprostenol analog for primary pulmonary hypertension. J Cardiovasc Pharmacol 2003; 41: 293-9. (In 3 trials of iv or sc treprostinil in comparison to iv epoprostenol or placebo in a total of 65 patients with PAH, both iv and sc treprostinil had similar efficacy to epoprostenol and was superior to placebo in improving exercise capacity and hemodynamics, while side effects included infusion site pain, erythema or induration in most patients receiving treprostinil [88% to 94%]; no mention of ALT elevations or hepatotoxicity). 12548091
Leuchte HH, Behr J. Iloprost for idiopathic pulmonary arterial hypertension. Expert Rev Cardiovasc Ther 2005; 3: 215-23. (Review of the structure, mechanism of action, acute hemodynamic effects, clinical efficacy and safety of aerosolized iloprost as therapy of PAH does not mention serum enzyme elevations or hepatotoxicity). 15853595
Gomberg-Maitland M, Preston IR. Prostacyclin therapy for pulmonary arterial hypertension: new directions. Semin Respir Crit Care Med 2005; 26: 394-401. (Review of prostacyclin analog therapy of PAH including iv epoprostenol, iv and sc treprostinil and inhaled iloprost; no mention of serum enzyme elevations during therapy or hepatotoxicity). 16121316
Barst RJ, Galie N, Naeije R, Simonneau G, Jeffs R, Arneson C, Rubin LJ. Long-term outcome in pulmonary arterial hypertension patients treated with subcutaneous treprostinil. Eur Respir J 2006; 28: 1195-203. (Among 860 patients with PAH treated with sc treprostinil for up to 4 years, survival was 68-87%, much higher than the predicted rates of 38-69% and side effects were similar to those reported in short term trials; “all mean chemistry…values were within normal ranges throughout the 4 years of treatment”). 16899485
McLaughlin VV, Oudiz RJ, Frost A, Tapson VF, Murali S, Channick RN, Badesch DB, et al. Randomized study of adding inhaled iloprost to existing bosentan in pulmonary arterial hypertension. Am J Respir Crit Care Med 2006; 174: 1257-63. (Among 67 patients with PAH on bosentan who were treated with inhaled iloprost or placebo for 12 weeks, iloprost improved exercise capacity and delayed time to clinical worsening and “no patient had significant liver function tests elevations”). 16946127
Voswinckel R, Enke B, Reichenberger F, Kohstall M, Kreckel A, Krick S, Gall H, et al. Favorable effects of inhaled treprostinil in severe pulmonary hypertension: results from randomized controlled pilot studies. J Am Coll Cardiol 2006; 48: 1672-81. (Among 123 patients with PAH enrolled in 3 studies of inhaled treprostinil, pulmonary vascular resistance declined in each and tolerability was considered “excellent”). 17045906
Lang I, Gomez-Sanchez M, Kneussl M, Naeije R, Escribano P, Skoro-Sajer N, Vachiery JL. Efficacy of long-term subcutaneous treprostinil sodium therapy in pulmonary hypertension. Chest 2006; 129: 1636-43. (Among 122 patients with PAH treated with sc treprostinil for up to 3 years, symptom relief was maintained and side effects included injection site pain; no mention of serum enzyme elevations or hepatotoxicity). 16778286
Tapson VF, Gomberg-Maitland M, McLaughlin VV, Benza RL, Widlitz AC, Krichman A, Barst RJ. Safety and efficacy of IV treprostinil for pulmonary arterial hypertension: a prospective, multicenter, open-label, 12-week trial. Chest 2006; 129: 683-8. (Among 16 patients with PAH treated with iv treprostinil for 12 weeks, exercise capacity and hemodynamics improved and side effects included jaw and extremity pain, nausea, headache, dizziness, diarrhea and flushing; no mention of serum enzyme elevations or hepatotoxicity). 16537868
Centers for Disease Control and Prevention (CDC). Bloodstream infections among patients treated with intravenous epoprostenol or intravenous treprostinil for pulmonary arterial hypertension--seven sites, United States, 2003-2006. MMWR Morb Mortal Wkly Rep 2007; 56: 170-2. (In a retrospective review of bloodstream infections at 7 centers in the US between 2003 and 2006, 144 cases [including 2 deaths] were identified in patients with PAH receiving infusions of prostacyclin analogs, rates being higher for treprostinil than epoprostenol). 17332729
Benza RL, Rayburn BK, Tallaj JA, Pamboukian SV, Bourge RC. Treprostinil-based therapy in the treatment of moderate-to-severe pulmonary arterial hypertension: long-term efficacy and combination with bosentan. Chest 2008; 134: 139-45. (Among 38 patients with PAH treated with sc infusions of treprostinil for up to 5 years, exercise capacity and hemodynamics were maintained and bosentan could be added “without serious adverse events”). 18403673
Walsh M, Hanna BD. A pediatric case study of treprostinil overdose. J Heart Lung Transplant 2009; 28: 297-8. (A 10 year old girl with PAH mistakenly received an overdose of iv treprostinil with immediate symptoms of tingling, blurred vision and poor motor control with rapid improvement on stopping the infusion and no apparent long lasting effects; no mention of liver injury or results of serum enzymes). 19285625
Olschewski H. Inhaled iloprost for the treatment of pulmonary hypertension. Eur Respir Rev 2009; 18: 29-34. (Review of the clinical efficacy and safety of inhaled iloprost in PAH mentions that side effects are generally mild and similar to those with other prostacyclin analogs). 20956120
Olschewski H, Hoeper MM, Behr J, Ewert R, Meyer A, Borst MM, Winkler J, et al. Long-term therapy with inhaled iloprost in patients with pulmonary hypertension. Respir Med 2010; 104: 731-40. (Among 63 patients with PAH treated with inhaled iloprost [6-9 times daily] for up to 2 years, most [95%] had at least one adverse event, most commonly cough, headache, infection, dizziness, nausea, edema and throat pain, but there were no hepatic serious adverse effects or drug discontinuations for liver related events). 20153158
Kingman MS, Tankersley MA, Lombardi S, Spence S, Torres F, Chin KS; Prostacyclin Safety Group. Prostacyclin administration errors in pulmonary arterial hypertension patients admitted to hospitals in the United States: a national survey. J Heart Lung Transplant 2010; 29: 841-6. (Surveys of physicians and nurses specializing in PAH care found that prostacyclin pump or dosing errors in epoprostenol and treprostinil administration were common and potentially serious, and were thought to have contributed to 9 patient deaths). 20430649
Tapson VF, Torres F, Kermeen F, Keogh AM, Allen RP, Frantz RP, Badesch DB, et al. Oral treprostinil for the treatment of pulmonary arterial hypertension in patients on background endothelin receptor antagonist and/or phosphodiesterase type 5 inhibitor therapy (the FREEDOM-C study): a randomized controlled trial. Chest 2012; 142: 1383-90. (Among 350 patients with PAH on stable therapy with an endothelin receptor antagonist or phosphodiesterase 5 inhibitor who were treated with oral treprostinil or placebo for 16 weeks, symptoms and exercise capacity improved with treprostinil and side effects included headache, nausea, diarrhea, flushing, jaw pain and myalgia, but there were no changes in “laboratory parameters” and no discontinuations for liver related events). 22628490
de Jesus Perez VA, Rosenzweig E, Rubin LJ, Poch D, Bajwa A, Park M, Jain M, et al. Safety and efficacy of transition from systemic prostanoids to inhaled treprostinil in pulmonary arterial hypertension. Am J Cardiol 2012; 110: 1546-50. (Among 18 patients with PAH who were switched from parenteral to inhaled treprostinil, most had no worsening of symptoms and side effects improved). 22853986
Kitterman N, Poms A, Miller DP, Lombardi S, Farber HW, Barst RJ. Bloodstream infections in patients with pulmonary arterial hypertension treated with intravenous prostanoids: insights from the REVEAL REGISTRY®. Mayo Clin Proc 2012; 87: 825-34. (Analysis of data from a prospective registry on PAH therapy identified 166 episodes of bloodstream infection in 123 patients among 1146 who were receiving iv prostacyclin analog therapy, use of treprostinil being associated with a 3-fold increased risk). 22883740
Sadushi-Kolici R, Skoro-Sajer N, Zimmer D, Bonderman D, Schemper M, Klepetko W, Glatz J, et al. Long-term treatment, tolerability, and survival with sub-cutaneous treprostinil for severe pulmonary hypertension. J Heart Lung Transplant 2012; 31: 735-43. (Among 111 patients with PAH treated with sc treprostinil for up to 10 years, 12% stopped because of adverse effects including infusion site reactions and pain and diarrhea; no mention of serum enzyme elevations or hepatotoxicity). 22480725
Tapson VF, Jing ZC, Xu KF, Pan L, Feldman J, Kiely DG, Kotlyar E, et al.; FREEDOM-C2 Study Team. Oral treprostinil for the treatment of pulmonary arterial hypertension in patients receiving background endothelin receptor antagonist and phosphodiesterase type 5 inhibitor therapy (the FREEDOM-C2 study): a randomized controlled trial. Chest 2013; 144: 952-8. (Among 310 patients with PAH on stable therapy with oral agents who were treated with oral treprostinil or placebo, exercise tolerance and symptoms did not improve with treprostinil, while side effects included headache [71%], diarrhea [55%], nausea [46%], flushing [35%], and jaw pain [25%]; there were no liver related serious adverse events). 23669822
Sammut D, Elliot CA, Kiely DG, Armstrong IJ, Martin L, Wilkinson J, Sephton P, Jones J, Hamilton N, Hurdman J, McLellan E, Sabroe I, Condliffe R. Central venous catheter-related blood stream infections in patients receiving intravenous iloprost for pulmonary hypertension. Eur J Clin Microbiol Infect Dis 2013; 32: 883-9. (Among 59 patients with PAH receiving iv iloprost over a 5 year period, 15 episodes of catheter related blood stream infections occurred in 11 patients for a rate of 0.65 per 1000 treatment days; there were no deaths). 23388830
Jing ZC, Parikh K, Pulido T, Jerjes-Sanchez C, White RJ, Allen R, Torbicki A, et al. Efficacy and safety of oral treprostinil monotherapy for the treatment of pulmonary arterial hypertension: a randomized, controlled trial. Circulation 2013; 127: 624-33. (Among 349 patients with PAH on no therapy who were treated with oral treprostinil or placebo for 12 weeks, exercise capacity improved, but there were no changes in symptoms or clinical status and side effects were common; there were no liver related serious adverse events or deaths). 23307827
Chin KM, Badesch DB, Robbins IM, Tapson VF, Palevsky HI, Kim NH, Kawut SM, et al. Two formulations of epoprostenol sodium in the treatment of pulmonary arterial hypertension: EPITOME-1 (epoprostenol for injection in pulmonary arterial hypertension), a phase IV, open-label, randomized study. Am Heart J 2014; 167: 218-225.e1. (Among 30 patients with PAH treated with 1 of 2 formulations [arginine- vs glycine-mannitol excipients] of iv epoprostenol for 28 days, exercise capacity and hemodynamics improved similarly in both groups and side effect rates were not different). 24439983
Hill NS, Badesch D, Benza RL, D'Eletto TA, Farber HW, Gomberg-Maitland M, Hassoun PM, et al. Perspectives on oral pulmonary hypertension therapies recently approved by the U.S. Food and Drug Administration. Ann Am Thorac Soc 2015; 12: 269-73. (Review of recently approved drugs for PAH including macitentan, riociguat and oral treprostinil mentions that dosing of oral treprostinil is complex and can result in suboptimal therapeutic levels, making the oral form of treprostinil not recommended as a first line agent for PAH). 25590376
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bosentan, but none to other agents used primarily to treat pulmonary artery hypertension). 25754159
Das A, Shabbir A, Sehgal S, Highland KB. Cutaneous hypersensitivity and eosinophilia associated with treprostinil. Pulm Pharmacol Ther 2015; 35: 17-8. (59 year old woman with scleroderma and PAH on sildenafil and macitentan was treated with iv followed by oral treprostinil for 3 months when she developed rash and eosinophilia [22%], that did not improve on switching back to the iv formulation, but resolved promptly when treprostinil was stopped; no mention of systemic signs or liver test abnormalities). 26407925
Bourge RC, Waxman AB, Gomberg-Maitland M, Shapiro SM, Tarver JH 3rd, Zwicke DL, Feldman JP, et al. Treprostinil administered to treat pulmonary arterial hypertension using a fully implantable programmable intravascular delivery system: results of the DelIVery for PAH Trial. Chest 2016; 150: 27-34. (Among 60 patients with severe PAH treated with iv treprostinil using a fully implantable deliver device for 12 months, 6 catheter complications arose, but no bloodstream infections or thromboses; no mention of serum enzyme elevations or hepatotoxicity). 27396777
O'Connell C, Amar D, Boucly A, Savale L, Jaïs X, Chaumais MC, Montani D, et al. Comparative safety and tolerability of prostacyclins in pulmonary hypertension. Drug Saf 2016; 39: 287-94. (Review of the clinical efficacy and safety of the prostacyclin analogs used to treat PAH including iloprost, epoprostenol and treprostinil; no mention of serum enzyme elevations occurring during therapy or hepatotoxicity). 26748508
Parikh KS, Rajagopal S, Fortin T, Tapson VF, Poms AD. Safety and tolerability of high-dose inhaled treprostinil in pulmonary hypertension. J Cardiovasc Pharmacol 2016; 67: 322-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2026828324) (Among 80 patients treated with inhaled treprostinil [>9 breaths, 4 times daily] for an average of 20 months, chronic side effects included cough, headache, flushing, nausea, throat irritation, jaw pain, diarrhea, dizziness, syncope and hypotension; no mention of serum enzyme elevations or hepatotoxicity).
Grünig E, Benjamin N, Lange TJ, Krueger U, Klose H, Neurohr C, Wilkens H, et al. Safety, tolerability and clinical effects of a rapid dose titration of subcutaneous treprostinil therapy in pulmonary arterial hypertension: a prospective multi-centre trial. Respiration 2016; 92: 362-70. (Among 39 patients with PAH on stable doses of oral therapies, addition of sc treprostinil in a rapid dose titration was associated with improved exercise capacity and hemodynamics and “a good overall safety profile”, although all patients had adverse events including infusion site pain in 97%, diarrhea in 77% and headache in 69%; no mention of ALT elevations or hepatotoxicity). 27784026

## OTHER REFERENCE LINKS

1. Recent References on Prostacyclin Analogs: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Prostacyclin%20Analogs+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Prostacyclin Analogs: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Prostacyclin%20Analogs)